# Pennyroyal Oil

## OVERVIEW

### Introduction

Pennyroyal is an herbal extract or oil derived from leaves of the plant in the mint genus (Mentha pulegium) that was used in the past as an insect repellent and an abortifacient. When taken by mouth, pennyroyal oil is highly toxic and has been linked to several instances of toxic liver injury and death.

### Background

Pennyroyal is derived from leaves of either Mentha pulegium or Hedeoma pulegoides, plants of the mint family that are native to Europe. Pennyroyal extract contains many components, but primarily contains the volatile oil pulegone and other monoterpenes. Pennyroyal has a strong fragrance similar to spearmint and was used for centuries to flavor food, wine and herbal teas. Pennyroyal extracts were also used as a traditional herb and folk remedy; a particular use was to stimulate menstruation and, in higher concentrations, to induce abortion. Pennyroyal tea and leaf extracts have been used without serious side effects. Pennyroyal oil, however, is highly toxic, and even small doses (one tablespoon, 15 mL) can cause syncope, seizures, coma, cardiopulmonary collapse, acute liver injury, renal insufficiency and multiorgan failure. Currently, pennyroyal oil is used in aromatherapy, as a bath additive and as an insect repellent, but is not recommended to be taken internally.

### Hepatotoxicity

There have been many reported cases of pennyroyal oil toxicity, usually arising within a few hours of ingestion. Cardiovascular collapse with disseminated intravascular coagulation is the usual presentation, but some patients develop acute liver injury with marked elevations in serum aminotransferase levels and early signs of liver failure, such as prolongation of the prothrombin time and hepatic encephalopathy. The clinical pattern of liver injury is acute hepatic necrosis that, if severe, can lead to acute liver failure and death. Immunoallergic features are uncommon. Liver biopsy shows marked centrilobular necrosis which can resemble shock or acute acetaminophen overdose.

Likelihood score: B (likely cause of acute, clinically apparent liver injury).

### Mechanism of Injury

Pennyroyal is clearly a direct cytotoxin. The toxic principal in pennyroyal oil appears to be pulegone which is converted by the cytochrome P450 system (CYP 1A2 and 2E1) to other hepatotoxins (menthofuran). Pulegone and its products deplete glutathionine levels and attempts at treating pennyroyal toxicity with N-acetyl cysteine infusions are appropriate. Pennyroyal oil contains 85% pulegone and can cause acute multiorgan injury, including acute hepatic necrosis in experimental animals.

### Outcome and Management

Pennyroyal oil is not recommended for oral intake, but cases of hepatotoxicity continue to be reported, largely from accidental or suicidal intake of the aromatic oil and rarely from its use as an abortifacient. Glutathionine has been shown to detoxify the toxic metabolites of pulegone and N-acetylcysteine should be administered in a manner similar to what is recommended for acetaminophen overdose. Cases were first reported more than 100 years ago; few have been published in the last two decades.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Acute hepatitis due to pennyroyal oil.(1)

An 18 year old girl developed nausea, vomiting, abdominal pain, agitation and confusion starting a few hours after taking one ounce of pennyroyal oil in an attempt to induce abortion. She had drunk pennyroyal tea many times in the past to induce menstruation. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis, but had been depressed, and the ingestion of pennyroyal oil may have been a suicide attempt. On examination, vital signs were stable except for tachypnea. Laboratory tests including serum aminotransferase levels were normal except for a metabolic acidosis. Approximately 40 hours after admission, she was found to have evidence of disseminated intravascular coagulation with prothrombin time of 32 seconds, low fibrinogen levels and platelet count of 10,000/μL. At this point, serum enzyme levels were markedly elevated although serum bilirubin was only 1.2 mg/dL (Table). Over the next few days, the liver tests worsened and she developed progressive renal insufficiency, pulmonary failure and coma requiring intubation. She suffered recurrent cardiopulmonary arrest and multiorgan failure from which she died 7 days after the ingestion. Autopsy showed petechiae in multiple organs, pulmonary consolidation and massive centrilobular hepatic necrosis and rupture of the liver with 4.5 L of blood in the peritoneum.

#### Key Points

Medication: | Pennyroyal oil (one ounce)
Pattern: | Hepatocellular (R=110)
Severity: | 5+ (jaundice, hospitalization, death from multiorgan and hepatic failure)
Latency: | Within 24 hours
Recovery: | None
Other medications: | None

#### Laboratory Values

Time After Ingestion | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
<4 hours | Normal | Normal | Normal | Normal | Acidosis
2 days | | 5,960 | 80 | 1.2 | LDH 7960 U/L
3 days | 4,400 | 10,160 | 93 | 6.1 | Protime 19 sec
4 days | 1,240 | 1,060 | | 12.0 | Creatinine 3.7 mg/dL
5 days | | Cardiopulmonary arrest, resuscitated
7 days | | Cardiopulmonary arrest, death
Normal | <40 | <40 | <130 | <1.2

#### Comment

The tragic course and outcome of the pennyroyal oil poisoning resembled acetaminophen overdose, with acute hepatic necrosis arising two to three days after the ingestion of the herbal oil accompanied by renal failure, metabolic acidosis and generalized collapse. The finding of centrilobular necrosis on autopsy also resembles acetaminophen overdose, but is also compatible with acute ischemic necrosis. The hepatic rupture was perhaps due to the extensive hepatic necrosis and possibly the cardiopulmonary resuscitation efforts.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pennyroyal Oil – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (http://www.nlm.nih.gov/medlineplus/druginfo/natural/480.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pennyroyal | 8007-44-1 | Herbal mixture | Not applicable

## CITED REFERENCE

1 Sullivan JB, Rumack BH, Thomas H, Peterson RG, Bryson P. (1979). Pennyroyal oil poisoning and hepatotoxicity. JAMA.

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; pennyroyal oil is discussed as an ostensible abortifacient that has toxicity that can be reproduced in experimental animals).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that pennyroyal hepatotoxicity may be due to depletion of glutathione by pulegone).
Pennyroyal. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 639-40. (Compilation of short monographs on herbal medications and dietary supplements).
Girling J. (1887). Poisoning by pennyroyal. Br Med J. (40 year old woman went into coma an hour after taking pennyroyal oil, responding to hypodermic injections of apomorphine and brandy).
Flynn EF. (1893). Poisoning by essence of pennyroyal. Br Med J. (A “small, delicate woman” took pennyroyal oil for abortion and developed agitation, fright and weakness, responding to emetics).
Allen WT. (1897). Note on a case of supposed poisoning by pennyroyal. Lancet. (23 year old woman developed vomiting followed by collapse a few hours after swallowing a tablespoon of pennyroyal oil, dying 8 days after ingestion).
Braithwaite PF. (1906). A case of poisoning by pennyroyal: recovery. Br Med J. (Young woman took half an ounce of essence of pennyroyal to induce menstruation and developed nausea, vomiting, confusion and stupor, responding to emetics).
Vallance WB. (1955). Pennyroyal poisoning: a fatal case. Lancet. (24 year old woman developed fatigue and vomiting a few hours after taking pennyroyal oil to induce abortion and, failing that, underwent an abortion followed by excessive bleeding, fever and rash, with subsequent renal failure and death 10 days later; on autopsy, there was acute tubular necrosis, “the liver appeared relatively normal”).
Early DF. (1961). Pennyroyal: a rare cause of epilepsy. Lancet. (23 year old woman had multiple seizures followed by an acute psychotic reaction after taking pennyroyal oil 3-4 times daily for 4 days, ultimately resolving completely; author quotes 3 previous reports of seizures following pennyroyal use).
Mack RB. (1997). "Boldly they rode ... into the mouth of hell". Pennyroyal oil toxicity. N C Med J. (Review of pennyroyal oil toxicity and suspected mechanism of injury and possible role of glutathione depletion).
Centers for Disease Control. (1978). Fatality and illness associated with consumption of pennyroyal oil–Colorado. MMWR Morb Mortal Wkly Rep. (Three unrelated cases of women taking 0.25-1 ounce of pennyroyal oil in unsuccessful attempts to induce abortion; ages 18, 21 and 24 years, developing nausea, dizziness and paresthesias a few hours after ingestion, 2 recovering rapidly with normal liver tests, one developing acute liver failure and dying after 6 days, autopsy showing massive hepatic necrosis).
Sullivan JB, Rumack BH, Thomas H, Peterson RG, Bryson P. (1979). Pennyroyal oil poisoning and hepatotoxicity. JAMA. (Two cases of pennyroyal oil overdose in abortion attempts: 18 year old took one ounce of pennyroyal oil developed nausea and agitation, with progressive acidosis and hematemesis [bilirubin 1.8 mg/dL, AST 5960 U/L, LDH 7960 U/L, Alk P 80 U/L] in first few hours progressing to hepatic failure and cardiovascular collapse by day 6 [Case 1]; 22 year old woman developed dizziness after ingesting 10 mL of pennyroyal oil, but had normal laboratory values and was discharged in 2 days; probably 2 of 3 cases which were also described in MMWR [1978]).
Gold J, Cates W. (1980). Herbal abortifacients. JAMA. (Editorial on Sullivan et al. [1979] from the CDC stating that this was the first report of a death after use of an abortifacient and it is unclear why herbal medicines are used for this purpose in view of the availability of legal abortions).
Gordon WP, Fort AJ, McMurtrey RJ, Gal J, Nelson SD. (1982). Hepatotoxicity and pulmonary toxicity of pennyroyal oil and its component terpenes in the mouse. Toxicol Appl Pharmacol. (In mice, (R)-(+)-pulegone [the major terpene in pennyroyal oil] is toxic to lung and liver, causing central necrosis and marked ALT elevations accompanied by glutathione depletion).
Buechel DW, Haverlah VC, Gardner ME. (1983). Pennyroyal oil ingestion: report of a case. J Am Osteopath Assoc. (20 year old woman took pennyroyal in tea for 2 weeks to induce menstruation and then 15 capsules at once to induce menstruation, developing nausea, weakness and syncope within hours, with normal liver tests, treated with N-acetylcysteine and recovering within 24 hours).
Bakerink JA, Gospe SM, Dimand RJ, Eldridge MW. (1996). Multiple organ failure after ingestion of pennyroyal oil from herbal tea in two infants. Pediatrics. (Two cases of severe pennyroyal toxicity in infants, 8 week and 6 months old, who were treated with locally prepared mint tea for respiratory illness and developed metabolic acidosis, seizures and multiorgan failure [bilirubin 2.9 and 1.4 mg/dL, ALT 2856 and 2013 U/L, Alk P 307 U/L, LDH 9055 and 2231 U/L], one dying and one surviving with neurologic deficits; one tea was shown to contain pulegone).
Anderson IB, Mullen WH, Meeker JE. (1996). Khojasteh-BakhtSC, Oishi S, Nelson SD, Blanc PD. Pennyroyal toxicity: measurement of toxic metabolite levels in two cases and review of the literature. Ann Intern Med. (Four cases of pennyroyal toxicity; 24 year old woman took pennyroyal oil to induce abortion and developed nausea, syncope and cardiopulmonary arrest and later died of multiorgan failure [AST rising from 49 to 2672 U/L], autopsy showing centrilobular necrosis; 22 month old girl drank pennyroyal oil and was treated with gastric lavage and N-acetylcysteine within an hour and thereafter had no liver test abnormalities; two other cases had mild dizziness and gastrointestinal symptoms after pennyroyal tea ingestion).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interaction; pennyroyal oil is said to be widely available and used as an abortifacient as well as a pesticide and general herbal tonic).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including pennyroyal oil which typically causes severe gastrointestinal upset and central nervous system effects within 1-2 hours of ingestion of 10 mL or more, hepatic dysfunction becomes prominent later).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal oil [1], skullcap [2], Chinese herbs [9], valerian [1]).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, including pennyroyal oil which is known to be hepatotoxic, although most cases of toxicity have gastrointestinal distress and central nervous system dysfunction).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but no case was attributed to pennyroyal oil alone or in combination with other agents).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none due to pennyroyal oil).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; pennyroyal oil is listed as a potential hepatotoxin but not specifically discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including four publications on pennyroyal).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that pennyroyal oil can cause severe central nervous system effects, hepatic necrosis and multiorgan failure).
Gordon P, Khojasteh SC. (2015). A decades-long investigation of acute metabolism-based hepatotoxicity by herbal constituents: a case study of pennyroyal oil. Drug Metab Rev. (Chemical component analysis and in vivo testing of pennyroyal oil indicates that the major cytotoxin is the terpene pulegone which constitutes ~80% of the oil and which is metabolized by CYP 2E1 to menthofuran, which is highly hepatoxic in rodent models).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that pennyroyal has long been known to be toxic and capable of causing acute hepatic necrosis in a pattern similar to acetaminophen, the toxic components being pulegone and menthofuran).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to pennyroyal).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not list those attributed to pennyroyal).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists pennyroyal [mentha puleium] as capable of causing rapid onset of acute hepatic necrosis, particularly in children and pregnant women).

## OTHER REFERENCE LINKS

1 Recent References on Pennyroyal Oil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pennyroyal+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pennyroyal Oil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pennyroyal)